# Evinacumab

## OVERVIEW

### Introduction

Evinacumab is a human monoclonal antibody to angiopoietin-like protein 3 which is approved for use in patients with homozygous familial hypercholesterolemia. Evinacumab is given intravenously every 4 weeks and is generally well tolerated, and has not been associated with serum aminotransferase elevations during therapy or with instances of clinically apparent liver injury.

### Background

Evinacumab (e” vin ak’ ue mab) is a human monoclonal IgG4 antibody directed against angiopoietin-like protein 3 (ANGPTL3) which is a protein expressed largely in the liver that inhibits lipoprotein lipase and endothelial lipase activity, two endogenous lipases which break down lipids in serum. Inhibition of ANGPTL3 by evinacumab causes preservation of full activity of both lipases resulting in a decrease in serum cholesterol and triglycerides levels. In preregistration randomized, placebo controlled trials, evinacumab resulted in a 45% to 55% decrease in total and LDL-cholesterol in patients with severe homozygous familial hypercholesterolemia who were already receiving maximum tolerated amounts of lipid lowering agents. Therapy also decreased serum triglyceride levels to a similar extent. Evinacumab was approved for use as an adjunct to cholesterol lowering therapy of familial hypercholesterolemia in adults and children 12 years of age or older the United States in 2021. It continues to be evaluated as therapy for hypertriglyceridemia and for refractory forms (both familial and non-familial) of hypercholesterolemia. Evinacumab is available in single use vials of 345 mg in 2.3 mL or 1200 mg in 8 mL (both 150mg/mL) under the brand name Evkeeza. The recommended dose is 15 mg/kg given intravenously over 60 minutes every 4 weeks. It can be administered with other lipid lowering oral agents including statins, ezetimibe, niacin and anti-PCSK9 monoclonal antibodies. Common side effects of evinacumab include mild local injection reactions, rhinorrhea, nasopharyngitis, dizziness, nausea, fatigue, and pain in the extremities. Rare instances of severe hypersensitivity reactions including anaphylaxis was been reported.

### Hepatotoxicity

In preregistration randomized controlled studies, mild serum aminotransferase elevations arose a small percentage of treated patients but were generally asymptomatic and transient and did not require discontinuation or modification of dose. In addition, there were no reported instances clinically apparent liver injury or severe hepatic adverse events attributed to the therapy. Since approval and more general use of evinacumab there have been no reports of clinically significant liver injury attributed to its use, but the number of patients treated has been limited.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

Possible mechanisms of liver injury due to evinacumab are not apparent. Monoclonal antibodies and immunoglobulins are generally taken up and metabolized intracellularly to short peptides and amino acids.

Drug Class: Monoclonal Antibodies, Antilipemic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Evinacumab – Evkeeza®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Evinacumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Evinacumab | 1446419-85-7 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 08 July 2021

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of evinacumab).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/761181Orig1s000MedR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA clinical scientific review of the evinacumab application which mentions that there was “no evidence of CK, ALT, or AST elevation” with evinacumab and only ALT elevation above 5 times ULN occurred in a patient who had stopped therapy 3 months previously).
Dewey FE, Gusarova V, Dunbar RL, O'Dushlaine C, Schurmann C, Gottesman O, McCarthy S. (2017). Vet al. Genetic and pharmacologic inactivation of ANGPTL3 and cardiovascular disease. N Engl J Med. (Exon sequencing in large populations demonstrated rare loss-of-function mutations in the ANGPTL3 gene that was associated with lower levels of serum triglycerides and cholesterol and lower risk for coronary artery disease; inhibition of ANGPTL3 using evinacumab reduced triglyceride and cholesterol levels in a mouse model of dyslipidemia, and with similar effects were noted in a phase 1 trial in 83 patients with dyslipidemia, in which 7 of 62 subjects receiving evinacumab had transient serum ALT elevations).
Gaudet D, Gipe DA, Pordy R, Ahmad Z, Cuchel M, Shah PK, Chyu KY, et al. (2017). ANGPTL3 Inhibition in homozygous familial hypercholesterolemia. N Engl J Med. (Among 9 adults with homozygous familial hypercholesterolemia treated with evinacumab for 4 weeks, LDL cholesterol levels decreased by 49%, HDL cholesterol by 36%, and triglycerides by 47%; no mention of adverse events).
Ahmad Z, Banerjee P, Hamon S, Chan KC, Bouzelmat A, Sasiela WJ, Pordy R, et al. (2019). Inhibition of angiopoietin-like protein 3 with a monoclonal antibody reduces triglycerides in hypertriglyceridemia. Circulation. (Among 139 adults with hypertriglyceridemia enrolled in 2 studies of different single or multiple doses of evinacumab, there were no serious treatment related adverse events; serum ALT levels rose in 0-30% of evinacumab treated versus 0-8% of placebo recipients, but all elevations were self-limited and none required dose modification or were associated with clinically apparent liver injury).
Raal FJ, Rosenson RS, Reeskamp LF, Hovingh GK, Kastelein JJP, Rubba P, Ali S, et al. (2020). ELIPSE HoFH Investigators. Evinacumab for homozygous familial hypercholesterolemia. N Engl J Med. (Among 65 patients with homozygous familial hypercholesterolemia treated with intravenous evinacumab [15 mg/kg] vs placebo every 4 weeks for 24 weeks, changes in LDL cholesterol averaged -47% vs +1.9%, while adverse event rates were similar in both groups and ALT or AST elevations [all less than 5 times ULN] arose in 5% vs 10% and there were no treatment related serious adverse events).
Kersten S. (2020). Bypassing the LDL receptor in familial hypercholesterolemia. N Engl J Med. (Editorial on Raal et al [2000] stressing the rapid and dramatic decreases in total cholesterol and triglycerides that occur with evinacumab which has the advantage of acting independently of the LDL-receptor which makes it appropriate as therapy for homozygous familial hypercholesterolemia).
Rosenson RS, Burgess LJ, Ebenbichler CF, Baum SJ, Stroes ESG, Ali S, Khilla N, et al. (2020). Evinacumab in patients with refractory hypercholesterolemia. N Engl J Med. (Among 272 patients with refractory [non-familial] hypercholesterolemia treated with different dose regimens of sc or iv evinacumab or placebo for 16 weeks, optimal doses reduced LDL cholesterol levels by 47-50%, and adverse events were common but generally mild except for a single instance of acute anaphylaxis; no mention of ALT elevations or hepatotoxicity).
(2021). Evinacumab (Evkeeza) for homozygous familial hypercholesterolemia. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of evinacumab shortly after its approval for use in homozygous familial hypercholesterolemia in the US mentions common adverse events of nasopharyngitis, rhinorrhea, dizziness, nausea, infusion reactions, and rare instances of anaphylaxis; no mention of ALT elevations or hepatotoxicity).
Markham A. (2021). Evinacumab: first approval. Drugs. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of evinacumab shortly after its approval for use in familial hypercholesterolemia in the US, mentions adverse events of nasopharyngitis, rhinorrhea, dizziness, nausea, asthenia, pain in extremities and infusion reactions but does not mention ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Evinacumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Evinacumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Evinacumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Evinacumab)